# Hawthorn

## OVERVIEW

### Introduction

Hawthorn is a flowering shrub or tree of several Crataegus species, which has been used in traditional medicine for digestive complaints and heart disease including hypertension and heart failure. Oral forms of hawthorn extracts have not been linked to elevations in serum aminotransferase levels or to instances of clinically apparent liver injury with jaundice.

### Background

Hawthorn is bulky shrub or small tree of several species of the genus Crataegus (pinnatifida, laevigata, monogyna, oxyacantha), which is found throughout most of Asia, Europe and North America. Extracts of the dried ripe berries and leaves were used in ancient traditional Chinese medicine to treat indigestion, chest pain, and hernia. More recently it has been used largely to treat cardiovascular disease such as angina pectoris, hypertension, and congestive heart failure. The hawthorn berry is also used as a food, prepared as jam or jelly, and made into a fruit drink. Extracts of hawthorn berries and leaves contain multiple flavonoids, phenylpropanoids, lignans, triterpenoids and glycosides. The ingredient responsible for the purported activity of hawthorn in heart disease is unknown, but is suspected to be a flavonoid antioxidant. Studies in vitro and in vivo have shown that hawthorn extracts have multiple pharmacological actions, including cardiovascular protection and antioxidant, antibacterial, lipid lowering, and hepatoprotective activity. Clinical trials of hawthorn, however, have not consistently substantiated these medicinal properties. Hawthorn is found in multiple commercial forms, the recommended daily dose ranging widely from 120 to as high as 1800 mg of extract daily. Hawthorn is generally well tolerated without adverse events; minor side effects may include diarrhea, abdominal discomfort and nausea. Rare instances of hypersensitivity reactions, skin rash and allergic dermatitis have been described.

### Hepatotoxicity

In several prospective clinical trials, hawthorn in conventional oral doses was typically described as having no serious, drug related adverse side effects and serum enzyme elevations were not mentioned. In most studies, adverse events with hawthorn occurred at rates similar to or less than that with placebo, and no instances of serum enzyme elevations or clinically apparent liver injury were mentioned. Despite widespread use as an herbal supplement, hawthorn has not been implicated in cases of drug induced liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which hawthorn might cause liver injury is unknown. Hawthorn is a widely used food, and liver injury arising while taking a multiingredient, hawthorn containing product might be due to a contaminant or another herbal component in the dietary supplement.

Drug Class: Herbal and Dietary Supplements

Other names: English Hawthorn, Hawthorne, Haw.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hawthorn – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/hawthorn)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hawthorn | 90045-52-6 (https://pubchem.ncbi.nlm.nih.gov/substance/135318819) | Herbal | Not Applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 28 January 2023

Abbreviations: HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not hawthorn).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of Hawthorn).
English Hawthorn. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 279-84. (Compilation of short monographs on herbal medications and dietary supplements).
Stedman C. (2002). Herbal hepatotoxicity. Semin Liver Dis. (Review and description of patterns of liver injury due to herbals, including discussion of potential risk factors, and herb-drug interactions).
Holubarsch CJ, Colucci WS, Meinertz T, Gaus W, Tendera M. (2008). Survival and prognosis: investigation of Crataegus Extract WS 1442 in CHF (SPICE) trial study group. The efficacy and safety of Crataegus extract WS 1442 in patients with heart failure: the SPICE trial. Eur J Heart Fail. (Among 2681 adults with heart failure treated with a hawthorn extract or placebo for 24 months, the mean times to first cardiovascular event, rates of death from heart failure and hospitalizations for heart failure were the same in both groups as were total [67% vs 68] and severe adverse event rates [39% vs 41%]; no mention of ALT elevations or hepatotoxicity).
Zick SM, Vautaw BM, Gillespie B, Aaronson KD. (2009). Hawthorn Extract Randomized Blinded Chronic Heart Failure (HERB CHF) trial. Eur J Heart Fail. (Among 120 adults with chronic heart failure treated with a hawthorn extract [450 mg] or placebo twice daily for 6 months, there were no differences in rates of deaths or hospitalizations, or changes of symptoms and signs of heart failure while adverse events were more frequent with hawthorn [60% vs 38%], no mention of ALT elevations or hepatoxicity).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. (2009). Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf. (Review of 778 spontaneous reports of adverse reactions to herbals to Swedish Registry found no reports attributed to Hawthorn).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, including several herbal mixtures, usnic acid, Ma Huang, black cohosh, and Hydroxycut, but not Hawthorn).
Stickel F, Kessebohm K, Weimann R, Seitz HK. (2011). Review of liver injury associated with dietary supplements. Liver Int. (Review of current understanding of liver injury from herbals and dietary supplements focusing upon Herbalife and Hydroxycut products, green tea, usnic acid, noni juice, Chinese herbs, vitamin A and anabolic steroids; Hawthorn is not discussed).
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. (2012). Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but does not list or mention Hawthorn).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, 15 of which [16%] were attributed to HDS products, but none were listed as containing Hawthorn).
Bunchorntavakul C, Reddy KR. (2013). Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther. (Systematic review of literature on HDS associated liver injury does not mention Hawthorn).
Navarro VJ, Seeff LB. (2013). Liver injury induced by herbal complementary and alternative medicine. Clin Liver Dis. (Review of the epidemiology, regulatory status, diagnosis, pathogenesis and causes of liver injury from herbal products with specific discussion of conjugated linoleic acid, ephedra, germander, green tea, usnic acid, flavocoxid, aloe vera, chaparral, greater celandine, black cohosh, comfrey, kava, skullcap, valerian, noni juice, pennyroyal and traditional herbal remedies).
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. (2014). Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed specifically to Hawthorn).
Brown AC. (2017). Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not list or discuss Hawthorn).
Medina-Caliz I, Garcia-Cortes M, Gonzalez-Jimenez A, Cabello MR, Robles-Diaz M, Sanabria-Cabrera J, Sanjuan-Jimenez R, et al., Spanish DILI Registry. (2018). Herbal and dietary supplement-induced liver injuries in the Spanish DILI Registry. Clin Gastroenterol Hepatol. (Among 856 cases of hepatotoxicity enrolled in the Spanish DILI Registry between 1994 and 2016, 32 were attributed to herbal products, the most frequent cause being green tea [n=8] and Herbalife products [n=6], while one anicteric, self-limited hepatocellular case was scored as probably due to Hawthorn).
Holubarsch CJF, Colucci WS, Eha J. (2018). Benefit-risk assessment of Crataegus Extract WS 1442: an evidence-based review. Am J Cardiovasc Drugs. (Summary of the effects of a hawthorn extract [WS 1442] reporting evidence from post-hoc sub-analyses of large clinical trials in chronic heart failure mentions that in most studies adverse events were no greater than with placebo and in some instances were less frequent, indicating excellent safety and tolerance).
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. (2021). Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; hawthorn was not implicated in any cases).
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. (2022). Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while no case was attributed to hawthorn).
Kim E, Jang E, Lee JH. (2022). Potential roles and key mechanisms of hawthorn extract against various liver diseases. Nutrients. (Review of the possible roles of hawthorn in treating liver disease it having been found to have antioxidant activity and to decrease lipid accumulation in animal models of nonalcoholic fatty liver).
Zhang J, Chai X, Zhao F, Hou G, Meng Q. (2022). Food applications and potential health benefits of hawthorn. Foods. (Description of the numerous components of hawthorn, which is rich in vitamins A, C, B1 and B2 as well as aminoacids calcium and carotene and has more than 60 flavonoids).
Li R, Luan F, Zhao Y, Wu M, Lu Y, Tao C, Zhu L, Zhang C, Wan L. (2023). Crataegus pinnatifida: A botanical, ethnopharmacological, phytochemical, and pharmacological overview. J Ethnopharmacol. (Review of the botanical features, traditional usage, chemical composition, pharmacological actions, clinical efficacy and safety of Crataegus pinnatifida, mentions that C. pinnatifida has over 250 phytochemical components, causes liver injury when given in high doses to dogs, but has been used safely for centuries in China).

## OTHER REFERENCE LINKS

1 Recent References on Hawthorn: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Hawthorn+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Hawthorn: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hawthorn)